# Corticosteroids

## OVERVIEW

### Introduction

The corticosteroids are a group of chemically related natural hormones and synthetic agents that resemble the human adrenal hormone cortisol and have potent antiinflammatory and immunosuppressive properties and are widely used in medicine. Corticosteroid therapy is associated with several forms of liver injury, some due to exacerbation of an underlying liver disease and some that appear to be caused directly by corticosteroid therapy. This discussion will cover eight agents: betamethasone, cortisone, dexamethasone, hydrocortisone, methylprednisolone, prednisolone, prednisone, and triamcinolone.

### Background

The corticosteroids are hormones that have glucocorticoid (cortisol-like) and/or mineralocorticoid (aldosterone-like) activities and which are synthesized predominantly by the adrenal cortex. In clinical practice, the term “corticosteroids” usually refers to the glucocorticoids and are represented by a large group of natural or synthetic steroid compounds that have varying potency, durations of action and relative glucocorticoid (measured by antiinflammatory activity) vs mineralocorticoid (measured by sodium retention) activities. Cortisol and the corticosteroids act by engagement of the intracellular glucocorticoid receptor, which then is translocated to the cell nucleus where the receptor-ligand complex binds to specific glucocorticoid-response elements on DNA, thus activating genes that mediate glucocorticoid responses. The number of genes modulated by corticosteroids are many and the effects are multiple and interactive with other intracellular pathways. Thus, the effects of corticosteroids on inflammation and the immune system cannot be attributed to a single gene or pathway. The potent antiinflammatory and immunosuppressive qualities of the corticosteroids have made them important agents in the therapy of many diseases. Corticosteroids are available in multiple forms, including oral tablets and capsules; powders and solutions for parenteral administration; topical creams and lotions for skin disease; eye, ear and nose liquid drops for local application; aerosol solutions for inhalation and liquids or foams for rectal application. Representative corticosteroids (and the year of their approval for use in the United States) include cortisone (1950), prednisone (1955), prednisolone (1955), methylprednisolone (1957), dexamethasone (1958), betamethasone (1961), and hydrocortisone (1983). All are available in generic forms. In this website, only the oral and intravenous formulations of corticosteroids are described and they are discussed together with common list of references and representative case reports.

The corticosteroids are used widely in medicine largely for their potent antiinflammatory and immunosuppressive activities. The clinical conditions for which corticosteroids are used include, but are not limited to: asthma, systemic lupus erythematosus, rheumatoid arthritis, psoriasis, inflammatory bowel disease, nephritic syndrome, cancer, leukemia, organ transplantation, autoimmune hepatitis, hypersensitivity reactions, cardiogenic and septic shock, severe COVID-19 pneumonia, and, of course, glucocorticoid deficiency diseases such as in Addison’s disease and panhypopituitarism.

Corticosteroids are used in several liver diseases, most commonly in autoimmune hepatitis for which they have been shown to improve outcome and survival. Corticosteroids are also used after liver transplantation to prevent rejection. An important element in managing these liver diseases and conditions is to maintain the dose of corticosteroids at the lowest effective level. The adverse effects of long term corticosteroid therapy (which are rarely hepatic) are still major causes of morbidity and even mortality in these conditions.

Prednisone, prednisolone, methylprednisolone and triamcinolone are the most commonly used oral agents as they are inexpensive, rapid in onset, intermediate in duration of action and have potent glucocorticoid with minimal mineralocorticoid activities, at least as compared to cortisone and hydrocortisone. Betamethasone and dexamethasone have greater glucocorticoid potency and less aldosterone-like activity than prednisone, but have a longer duration of action, and they are mostly used in topical or liquid forms for local application and in injectable forms for severe hypersensitivity reactions and inflammation. Methylprednisolone, dexamethasone, and hydrocortisone are most commonly used for intravenous administration, typically given in emergency or critical situations in which rapid and profound immunosuppression or antiinflammatory activity is needed. Intravenous methylprednisolone is used most commonly in treatment of Graves’ ophthalmopathy and multiple sclerosis. Dexamethasone is used commonly for severe COVID-19 pneumonia.

The table below provides the major forms of corticosteroids and their relative glucocorticoid and mineralocorticoid activity and equivalent daily doses.

RELATIVE POTENCIES OF CORTICOSTEROIDS
AGENT | GLUCOCORTICOID ACTIVITY | MINERALOCORTICOID ACTIVITY | EQUIVALENT ORAL OR INTRAVENOUS DOSE
Cortisol | 1 | 1 | 20
Cortisone | 0.8 | 0.8 | 25
Prednisone | 4 | 0.8 | 5
Prednisolone | 4 | 0.8 | 5
Methylprednisolone | 5 | 0.5 | 4
Triamcinolone | 5 | 0 | 4
Betamethasone | 25 | 0 | 0.75
Dexamethasone | 25 | 0 | 0.75

Cortisone (kor' ti sone) is a short acting glucocorticoid that is used for therapy of adrenal insufficiency and for treatment of allergic and inflammatory conditions. Cortisone is available in generic forms in tablets of 25 mg, which is considered a daily physiologic dose in adults. Cortisone has both glucocorticoid and mineralocorticoid properties.

Hydrocortisone (hye" droe kor' ti sone) is a rapid and short acting glucocorticoid that is used for therapy of adrenal insufficiency and in treatment of allergic and inflammatory conditions. Hydrocortisone has the same chemical structure as cortisol and thus most closely resembles the human adrenal hormone. Hydrocortisone is available in generic forms in tablets of 5, 10 and 20 mg, with 20 mg being considered a daily physiologic dose in adults. Hydrocortisone is also available in multiple forms in solution for oral, rectal, topical or parenteral administration. A major use of intravenous hydrocortisone is in the acute therapy of severe hypersensitivity reactions and shock. Hydrocortisone has both glucocorticoid and mineralocorticoid properties.

Prednisone (pred' ni sone) is a synthetic, intermediate acting glucocorticoid that is widely used in the therapy of severe inflammation, autoimmune conditions, hypersensitivity reactions and organ rejection. Prednisone is converted to prednisolone, its active form, in the liver. Prednisone is available in multiple generic forms in tablets of 1, 2.5, 5, 10, 20 and 50 mg and as oral solutions. Four times more potent that cortisol, prednisone is used in varying doses, with 5 mg daily being considered physiologic doses in adults.

Prednisolone (pred nis' oh lone) is a synthetic, intermediate acting glucocorticoid that is widely used in the therapy of severe inflammation, autoimmune conditions, hypersensitivity reactions and organ rejection. Prednisolone is available in multiple generic forms in tablets of 5, 10, 15 and 30 mg and in several forms for systemic administration. Four times more potent that cortisol, prednisolone is used in varying doses, with 5 mg daily being considered physiologic doses in adults.

Methylprednisolone (meth" il pred nis' oh lone) is a synthetic, intermediate acting glucocorticoid that is widely used in the therapy of severe inflammation, autoimmune conditions, hypersensitivity reactions and organ rejection. Methylprednisolone is available in multiple forms in tablets of 2, 4, 8, 16 and 32 mg generically and under the brand name of Medrol and in Medrol Dosepaks (21 tablets of 4 mg each). Injectable forms of methylprednisolone are also available generically and under brand names of Solu-Medrol and Depo-Medrol. Five times more potent that cortisol, methylprednisolone is used in varying doses, with 4 mg daily being considered physiologic doses in adults. Methylprednisolone has minimal mineralocorticoid activity.

Triamcinolone (trye" am sin' oh lone) is a synthetic, long acting glucocorticoid that is used in topical solutions and aerosols for therapy of allergic and hypersensitivity reactions and control of inflammation as well as in parenteral formulations for therapy of hypersensitivity reactions, shock and severe inflammation. Oral forms of triamcinolone include tablets of 4 and 8 mg and oral syrups. Parenteral forms for injection are available under various generic and trade names including Aristocort and Kenacort. Triamcinolone is five times more potent than cortisol in its glucocorticoid activity, but has minimal mineralocorticoid activity.

Dexamethasone (dex" a meth' a sone) is a synthetic, long acting glucocorticoid that is used parenterally as therapy of severe hypersensitivity reactions, shock and control of severe inflammation as well as in topical, otic, ophthalmologic solutions, aerosols and lotions or creams for local therapy of allergic reactions and inflammation. Most recently, intravenous dexamethasone has been found to be beneficial in severe COVID-19 pneumonia with respiratory failure in patients requiring high flow oxygen supplementation or invasive mechanical ventilation. Dexamethasone is available in multiple forms for injection under various generic and trade names including Decadron. Dexamethasone is 25 times more potent than cortisol in its glucocorticoid activity, but has minimal mineralocorticoid activity.

Betamethasone (bay" ta meth' a sone) is a synthetic, long acting glucocorticoid that is used in parenteral forms for therapy of allergic and hypersensitivity reactions and control of severe inflammation. Betamethasone is available in solution for injection under the trade name of Celestone and in multiple generic forms as syrups and effervescent tablets for oral use, edemas and foams for rectal use, aerosols for nasal and respiratory use, and creams and lotions for topical use. Betamethasone is 25 times more potent than cortisol in glucocorticoid activity, but has minimal mineralocorticoid activity.

### Hepatotoxicity, Mechanism of Injury

Corticosteroids have multiple adverse side effects, due to their multiplicity of actions affecting virtually all organs. Long term use has very profound effects on growth and can lead to cataracts, glaucoma, opportunistic infections, thinning of the skin, weight gain and redistribution of fat, insulin resistance and diabetes, hypertension, headache, psychiatric problems, sodium retention and peripheral edema; all of the clinical features of Cushing syndrome.

Corticosteroids also have major effects on the liver, particularly when given long term and in higher than physiologic doses. Glucocorticoid use can result in hepatic enlargement and steatosis or glycogenosis. Corticosteroids can trigger or worsen nonalcoholic steatohepatitis. Long term use can also exacerbate chronic viral hepatitis. Importantly, treatment with corticosteroids followed by withdrawal or pulse therapy can cause reactivation of hepatitis B and worsening or de novo induction of autoimmune hepatitis, both of which can be fatal. Finally, high doses of intravenous corticosteroids, largely methylprednisolone, have been associated with acute liver injury which can result in acute liver failure and death. Thus, the hepatic complications of corticosteroids are mostly associated with high intravenous dosing usually represent the worsening or triggering of an underlying liver disease and rarely are the result of drug hepatotoxicity.

Corticosteroid therapy can cause hepatic steatosis and hepatic enlargement, but this is often not clinically apparent, particularly in adults. This effect can occur quite rapidly and is rapidly reversed with discontinuation. High doses and long term use has been associated with the development or exacerbation of nonalcoholic steatohepatitis with elevations in serum aminotransferase levels and liver histology resembling alcoholic hepatitis with steatosis, chronic inflammation, centrolobular ballooning degeneration and Mallory bodies (Case 1). However, symptomatic or progressive liver injury from corticosteroid induced steatohepatitis is uncommon. Furthermore, corticosteroids may act to worsen an underlying nonalcoholic fatty liver disease rather than causing the condition de novo. The worsening may be due to direct effects of glucocorticoids on insulin resistance or fatty acid metabolism or may be the result of weight gain which is common with long term corticosteroid therapy. While simple steatosis induced by corticosteroids is rapidly reversible, steatohepatitis can be slow to resolve upon withdrawal of corticosteroids.

Corticosteroids in high doses can also cause hepatic glycogenosis, in which liver cells exhibit a homogenous appearance and stain strongly for glycogen (using PAS staining with and without diastase). Glycogenosis can also be associated with hepatomegaly (in children) and elevations in serum aminotransferase levels with minimal or no change in alkaline phosphatase or bilirubin levels. Glycogenosis is usually asymptomatic and does not appear to progress to chronic liver injury, cirrhosis or acute liver failure. While glycogenosis has been described largely in patients with poorly controlled type 1 diabetes, it also can occur acutely in patients started on high dose corticosteroids.

An important complication of corticosteroid therapy is the worsening of an underlying chronic viral hepatitis. In chronic hepatitis B, corticosteroids can induce increases in viral replication and serum hepatitis B virus (HBV) DNA levels while decreasing serum aminotransferase levels. Eventually, however, the increase in viral replication can worsen the underlying liver disease. Exacerbation of hepatitis becomes particularly evident when corticosteroids are withdrawn or lowered to physiological levels. As the immune system recovers, hepatitis worsens and serum aminotransferase levels can rise to greater than 10- to 20-fold elevated usually accompanied by a prompt decrease in HBV DNA levels. This flare of disease following withdrawal of corticosteroids can be severe and result in acute liver failure or significant worsening of chronic hepatitis and development of cirrhosis (Case 2). Indeed, even patients with the “inactive carrier states” (as shown by the presence of HBsAg in serum without HBeAg or detectable HBV DNA or any elevation in serum aminotransferase levels) can suffer severe reactivation of disease and acute liver failure as a result of a short course of high dose corticosteroids as occurs with cancer chemotherapy or with treatment of severe autoimmune conditions or even asthma, hay fever or allergic dermatitis. Reactivation of hepatitis B can be prevented by prophylactic use of antiviral therapy during the period of immunosuppression, but even this may not prevent some degree of liver injury.

Corticosteroids also appear to worsen the course of chronic hepatitis C, although in a less dramatic fashion than in chronic hepatitis B. Corticosteroid therapy leads to a rise in hepatitis C virus (HCV) RNA levels which may eventually cause worsening of the underlying liver disease. Chronic hepatitis C appears to be more severe and is particularly difficult to manage in patients receiving chemotherapy or immunosuppression, and corticosteroids are believed to be a major factor in this effect. Thus, corticosteroids should be avoided if possible in patients with underlying chronic viral hepatitis.

Corticosteroids are used in the therapy of autoimmune hepatitis and, therefore, are likely to be beneficial rather than harmful in patients with this disease. The difficulty arises when corticosteroids are stopped, which can cause a rebound exacerbation of the autoimmune hepatitis that is often severe and can be fatal. Importantly, there have been multiple reported instances of de novo appearance of severe autoimmune hepatitis in patients who received a short course or pulse of corticosteroids for another, unrelated condition (such as asthma or allergic reactions). In these situations, a mild and subclinical autoimmune hepatitis was likely present before corticosteroids were started, and the suppression of the disease followed by immune rebound caused the clinical presentation of the condition. These patients generally respond to restarting corticosteroids, but may require long term if not lifelong immunosuppressive treatment thereafter.

Finally, there have been several reports of an acute hepatitis-like liver injury arising after a short, high dose course of intravenous methylprednisolone that can be severe and even fatal, and in which viral hepatitis and autoimmune hepatitis cannot be clearly implicated (Case 3). The cause of this apparent hepatotoxicity is not known, but it may represent severe autoimmune hepatitis triggered by the sudden profound immunosuppression and subsequent immune reconstitution. Importantly, symptoms and jaundice develop 1 to 6 weeks after stopping methylprednisolone and the pattern of serum enzyme elevations is typically hepatocellular. These episodes can be symptomatic and severe. Immunoallergic manifestations are uncommon and autoantibodies may not be present. Several instances have resulted in acute liver failure resulting in death or need for emergency liver transplantation. But transient injury without symptoms can also occur accompanied by serum aminotransferase elevations that are 10 to 40 times the ULN. Restarting corticosteroids may be appropriate for this syndrome particularly if symptomatic, but this approach has not been evaluated systematically and many instances have resolved spontaneously. Recurrence of injury, often in a more rapid and severe form, arises upon reexposure to high dose pulse methylprednisolone. Strangely, it is not clear whether this syndrome can be induced by high dose intravenous prednisone or dexamethasone.

Likelihood score: A[HD] (well established cause of liver injury when given in high doses, either the result of reactivation of hepatitis B, or an acute hepatocellular injury after high dose intravenous treatment, particularly with methylprednisolone).

Drug Class: Corticosteroids, COVID-19 Drugs

Selected Drugs in the Class: Betamethasone, Cortisone, Dexamethasone, Hydrocortisone, Methylprednisolone, Prednisolone, Prednisone, Triamcinolone. Budesonide is also a corticosteroid but has not been linked to liver injury and is discussed separately in LiverTox.

## CASE REPORTS

### Case 1. Nonalcoholic steatohepatitis after long term corticosteroid therapy.(1)

A 34 year old woman with systemic lupus erythematosus was treated with betamethasone with good clinical response with improvements in rash, fatigue and laboratory tests. Over a 6 month period, the daily dosage was gradually decreased from 5 to 1.25 mg daily. Initially, her liver tests were normal, but with continued corticosteroid therapy, ALT and AST became mildly elevated (Table). However, after 16 months of therapy, serum aminotransferase levels were more than 5-fold elevated (ALT 256 U/L, AST 272 U/L) and she was readmitted for evaluation. Her weight had risen by 11 kilograms and she had firm hepatomegaly. Laboratory tests showed elevations in serum aminotransferase levels, but normal serum bilirubin, albumin, and prothrombin time. She had an abnormal glucose tolerance test (fasting glucose 118 mg/dL; 2 hour postprandial glucose 248 mg/dL). Testing for HBsAg was negative. She was known to be positive for antinuclear antibody (1:128). She denied alcohol use, which was confirmed by family members and friends. A liver biopsy showed marked steatosis with inflammation including neutrophils, occasional Mallory bodies and mild central sinusoidal and portal fibrosis. Weight loss led to slight decreases in serum ALT levels.

#### Key Points

Medication: | Betamethasone (1.25 mg daily)
Pattern: | Hepatocellular or mixed (R=~4.6)
Severity: | Mild (serum enzyme elevations only)
Latency: | Several months
Recovery: | Not mentioned
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Body Weight (kg) | ALT (U/L) | Alk P (U/L) | Albumin (g/dL) | Other
0 | 42.7 | 18 | 95 | 3.4
6 months | 52.2 | 58 | 62 | 3.9
16 months | 58.2 | 256 | 131 | 4.0 | Protime 10.4 sec
17 months | 55.5 | 134 | 76 | 4.2
Normal Values | | <40 | <85 | <3.5

#### Comment

This is an early, but well documented report of nonalcoholic steatohepatitis arising during corticosteroid therapy. The patient was evidently asymptomatic of liver disease, but the height of the serum aminotransferase elevations led to a hospital admission and liver biopsy. An issue is whether the liver disease was due to corticosteroid therapy directly or was the result of weight gain and insulin resistance caused by the therapy. Betamethasone is a synthetic, high potency glucocorticoid; 1.25 mg of betamethasone is roughly equivalent to 15 mg of prednisone.

### Case 2. Reactivation of chronic hepatitis B by corticosteroids.(2)

A 69 year old man with ulcerative colitis and the HBsAg carrier state developed jaundice and hepatitis after 9 months of continuous prednisolone therapy and shortly after intravenous pulse treatment with methylprednisolone. He was known to be a carrier of HBsAg with normal serum aminotransferase levels and no detectable HBeAg or HBV DNA in serum for several years. Because of relapsing ulcerative colitis, he was started on prednisolone therapy in tapering doses (60 mg daily down to 5 mg daily). Approximately 8 months into therapy, he received a 7 day course of intravenous methylprednisolone. One week later, while still on low doses of oral prednisolone, he developed fatigue and nausea. Liver tests, which had been normal, were markedly elevated with ALT 517 U/L, Alk P 356 U/L and bilirubin 3.98 mg/dL (Table). He was admitted. On examination, he was jaundiced and had mild mental dullness and asterixis. At this point, he tested positive for both HBsAg and HBeAg, and HBV DNA levels (which had been undetectable in the past) were markedly elevated (>100 million copies/mL). In addition he had IgM anti-HBc. Despite initiation of lamivudine therapy for hepatitis B and intensive medical management, he developed progressive liver failure, coagulopathy, hepatic coma and died 25 days after admission. Autopsy was refused.

#### Key Points

Medication: | Prednisolone, methylprednisolone
Pattern: | Hepatocellular (R=6.1)
Severity: | 5+ (fatal)
Latency: | 8 months of oral prednisone
Recovery: | None
Other medications: | 5-Aminosalicylic acid, isosorbide dinitrate, theophylline, insulin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Bilirubin (mg/dL) | Other
Pre | | <30 | <1.0 | HBV DNA <100 copies/mL
7 months | | 60 | <1.0 | Methylprednisolone bolus
8 months | | 180 | <1.0 | Prednisone: 5 mg daily
9 months | 0 | 517 | <1.0 | Alk P 356
| 30 days | 600 | 4 | Admission; HBeAg positive
| 32 days | 700 | 14
| 34 days | 830 | 20
10 months | 36 days | 1140 | 24
| 6 weeks | 980 | 34
| 7 weeks | 220 | 36
| 8 weeks | 50 | 41 | Died
Normal Values | | <4.5 | <1.2

* Results and time sequence estimated from Figure 1.

#### Comment

Reactivation of hepatitis B in an HBsAg carrier can be followed by a severe episode of hepatitis as immunosuppression is withdrawn. The clinical syndrome is similar to acute hepatitis B and IgM anti-HBc may become detectable. The diagnosis can be made based upon reappearance and/or marked rise in HBV DNA levels. Many cases present as "acute-on-chronic" liver failure rather than classical acute liver failure. The prognosis is poor and antiviral therapy appears to have little effect once hepatic failure is present. HBsAg carriers who undergo immunosuppressive therapy with prednisone should be given prophylaxis during the immunosuppression with an oral nucleoside analogue such as tenofovir or entecavir or monitored carefully and started on antiviral therapy if HBV DNA levels appear de novo or rise significantly (generally by more than 1-2 log_10_ IU/mL.

### Case 3. Severe acute hepatitis following bolus, high dose methylprednisone therapy.(3)

A 43 year old woman with Graves disease developed worsening ophthalmopathy despite adequate control of thyroid function. She received orbital radiotherapy and was started on cycles of intravenous methylprednisolone (15/mg/kg) given over two days every two weeks. After the sixth infusion (6 weeks after starting), she was found to have elevations in serum ALT (264 U/L) and AST (120 U/L) and the infusions were held. Over the next six weeks, serum aminotransferase levels rose further (Table), with no or only minor elevations in serum alkaline phosphatase, gamma glutamyltranspeptidase and bilirubin. However, the prothrombin index worsened (61%) and platelet count fell to 89,000/µL. Tests of hepatitis A, B and C were negative. Immunoglobulin levels were normal and tests for autoantibodies, including antinuclear antibody, smooth muscle antibody and liver-kidney microsomal antibody, were negative. A liver biopsy showed changes suggestive of chronic aggressive hepatitis with marked lymphocytic inflammation, interface hepatitis, and both focal and bridging necrosis. Because the histological and clinical features supported the diagnosis of severe autoimmune hepatitis, oral prednisone was initiated, with prompt improvements in serum aminotransferase levels. Prednisone doses were gradually reduced and ultimately withdrawn. Serum enzymes were normal within 2 months of starting prednisone and the dosage was gradually reduced and then withdrawn 3 months after initiation.

#### Key Points

Medication: | Methylprednisolone
Pattern: | Hepatocellular
Severity: | 1+ (serum enzyme elevations without jaundice)
Latency: | 6 weeks
Recovery: | 3 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | GGT (U/L) | Other
Pre | | Normal | Normal
3 cycles of two days of pulse methylprednisolone given 2 weeks apart
8 weeks | 2 weeks | 264 | 40
12 weeks | 6 weeks | 320 | 40
13 weeks | 7 weeks | 610 | 80 | Bilirubin and Alk P normal
14 weeks | 8 weeks | 1050 | 100 | ANA negative, Protime 61%
15 weeks | 9 weeks | 1419 | 183 | im prednisolone started
4 months | 10 weeks | 600 | | Oral prednisone
| 11 weeks | 260 | 100
5 months | 15 weeks | 65 | 50
6 months | 20 weeks | 40 | 40
Normal Values | | <45 | <50

* Values and time sequence estimated from Figure 1.

#### Comment

An example of an acute hepatitis-like syndrome arising after pulse methylprednisolone therapy. These episodes arise typically 2 to 4 weeks after an early cycle of pulse therapy, and range in severity from an asymptomatic and transient rise in serum aminotransferase levels to an acute hepatitis and even fulminant hepatic failure. In this instance, the marked and persistent rise in serum enzymes coupled with liver histology suggesting chronic hepatitis led to a diagnosis of new-onset autoimmune hepatitis, despite the absence of serum autoantibodies or hypergammaglobulinemia. Autoimmune hepatitis may initially present in this fashion, without the typical pattern of serum autoantibodies during the early, anicteric phase. The diagnosis was further supported by the prompt improvements in serum enzymes with prednisone therapy. The acute hepatitis-like syndrome that can occur after pulses of methylprednisolone is best explained as a triggering of an underlying chronic autoimmune hepatitis caused by the sudden and profound immunosuppression followed by rapid withdrawal. This syndrome can be severe, and fatal instances have been reported. Whether reinitiation of corticosteroid therapy with gradual tapering and withdrawal is effective in ameliorating the course of illness is unclear, but anecdotal reports suggest that they are beneficial and should be initiated promptly. Long term follow up of such cases is also necessary to document that the autoimmune hepatitis does not relapse once corticosteroids are ultimately withdrawn again.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Betamethasone – Generic, Celestone®

Cortisone – Generic

Dexamethasone – Generic, Decadron®

Hydrocortisone – Generic, Cortef®

Methylprednisolone – Generic, Medrol®

Prednisolone – Generic

Prednisone – Generic

Triamcinolone – Generic, Aristocort®, Kenacort®, Kenalog®

DRUG CLASS

Glucocorticoids, Synthetic

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Betamethasone) (Betamethasone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Betamethasone | 378-44-9 | C22-H29-F-O5
Cortisone | 53-06-5 | C21-H28-O5
Dexamethasone | 50-02-2 | C22-H29-F-O5
Hydrocortisone | 50-23-7 | C21-H30-O5
Methylprednisolone | 83-43-2 | C22-H30-O5
Prednisolone | 50-24-8 | C21-H28-O5
Prednisone | 53-03-2 | C21-H26-O5
Triamcinolone | 124-94-7 | C21-H27-F-O6

## CITED REFERENCES

1 Itoh S, Igarashi M, Tsukada Y, Ichinoe A. (1977). Nonalcoholic fatty liver with alcoholic hyaline after long-term glucocorticoid therapy. Acta Hepato-Gastroenterologica.
2 Hammond A, Ramersdorfer C, Palitzsch KD, Schölmerich J, Lock G. (1999). Dtsch Med Wochenschr.
3 Marinò M, Morabito E, Altea MA, Ambrogini E, Oliveri F, Brunetto MR, Pollina LE, et al. (2005). Autoimmune hepatitis during intravenous glucocorticoid pulse therapy for Graves' ophthalmopathy treated successfully with glucocorticoids themselves. J Endocrinol Invest.

## ANNOTATED BIBLIOGRAPHY

References updated: 07 May 2021

Zimmerman HJ. Corticosteroids. Drugs to treat rheumatic/musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 541. (Expert review of hepatotoxicity of corticosteroids, focusing upon fatty liver and alcoholic hyaline-like changes with high doses or long term low doses).
Chitturi S, Farrell GC. Corticosteroids. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 613-4. (Review of liver injury from corticosteroids mentions hepatic steatosis and acute liver injury following high dose methylprednisolone).
Schimmer BP, Funder JW. Adrenocortical steroids. ACTH, adrenal steroids, and pharmacology of the adrenal cortex. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1215-33. (Textbook of pharmacology and therapeutics).
Steinberg H, Webb WM, Rafsky HA. (1952). Hepatomegaly with fatty infiltration secondary to cortisone therapy: case report. Gastroenterology. (14 year old boy treated for rheumatic fever with cortisone developed marked hepatomegaly beginning on day 6, and by day 43 liver biopsy showed fat and inflammation, which resolved rapidly upon stopping therapy; liver biopsy 20 days later showed normal liver without steatosis).
Hill RB, Droke WA. (1963). Production of fatty liver in the rat by cortisone. Proc Soc Exp Biol Med. (Rats treated with cortisone developed fatty liver and increases in hepatic triglyceride levels).
Itoh S, Igarashi M, Tsukada Y, Ichinoe A. (1977). Nonalcoholic fatty liver with alcoholic hyaline after long-term glucocorticoid therapy. Acta Hepato-Gastroenterologica. (56 year old woman with systemic lupus treated with betamethasone for 16 months gained 24 pounds and developed insulin resistance, moderate increases in ALT [from 18 to 272 U/L] and Alk P [95 to 121 U/L] levels without jaundice; biopsy showed steatohepatitis and Mallory bodies: Case 1).
Iancu TC, Shiloh H, Dembo L. (1986). Hepatomegaly following short-term high-dose steroid therapy. J Pediatr Gastroenterol Nutr. (Among 140 children treated with prednisone [2-4 mg/kg/day], 19 developed hepatomegaly within 3-6 days, regressing with stopping treatment; liver biopsies showed glycogenosis and some degree of steatosis; no mention of ALT levels).
Hoofnagle JH, Davis GL, Pappas SC, Hanson RG, Peters M, Avigan MI, Waggoner JG, et al. (1986). A short course of prednisolone in chronic type B hepatitis. Report of a randomized, double-blind, placebo-controlled trial. Ann Intern Med. (Clinical trial of 4 week course of prednisolone [60 mg/day for 2 weeks, 30 mg/day for 2 weeks] in 15 patients with chronic hepatitis B found flares of hepatitis occurring in most patients 1-2 months after withdrawal that could be prolonged and lead to worsening of liver histology).
Wald JA, Farr RS. (1991). Abnormal liver-function tests associated with long-term systemic corticosteroid use in subjects with asthma. J Allergy Clin Immunol. (Retrospective analysis of 80 patients with asthma found mean ALT and Alk P levels were higher among 25 patients on “high dose” corticosteroids compared to those on no or low doses; 80% on high doses had at least one liver test abnormality compared to 23% on low doses and 5% on no corticosteroid therapy).
Koga Y, Kumashiro R, Yasumoto K, Shakado S, Ono N, Noguchi H, Nagata K, et al. (1992). Two fatal cases of hepatitis B virus carriers after corticosteroid therapy for bronchial asthma. Intern Med. (53 year old woman with asthma and HBsAg developed acute hepatitis 2-3 weeks after 1 month course of intravenous hydrocortisone [200-300 mg/day], with jaundice, hepatic failure and death 6 weeks later; 68 year old man with asthma and HBsAg developed symptoms and jaundice 1 month after 8 day course of intravenous hydrocortisone, with progression to acute liver failure and death).
Fong TL, Valinluck B, Govindarajan S, Charboneau F, Adkins RH, Redeker AG. (1994). Short-term prednisone therapy affects aminotransferase activity and hepatitis C virus RNA levels in chronic hepatitis C. Gastroenterology. (Among 10 patients with chronic hepatitis C treated with 7 week course of prednisone, most had rise in HCV RNA levels during therapy with fall in ALT and rebound afterwards, but without clinically apparent flares).
Gerolami R, Mambrini P, Barthet M, Jean-Pastor MJ, Salducci J, Grimaud JC. (1997). Gastroenterol Clin Biol. (27 year old woman with Crohn disease received methylprednisolone [50 mg/day] followed by intravenous prednisone [60 mg/day] and developed abnormal liver tests 6 days later, ALT levels rising from normal to 11 times ULN, Alk P to 3.2 times ULN, ANA negative, resolving within 1 week of starting oral corticosteroids; elevations possibly due to acute glycogenosis).
Hammond A, Ramersdorfer C, Palitzsch KD, Schölmerich J, Lock G. (1999). Dtsch Med Wochenschr. (69 year old man with HBsAg carrier state and ulcerative colitis developed jaundice and progressive hepatic failure starting at the end of a 9 month course of prednisone [60 mg down to 5 mg/day], with appearance of HBV DNA, ALT 1140 U/L, and death 30 days later: Case 2).
Nanki T, Koike R, Miyasaka N. (1999). Subacute severe steatohepatitis during prednisolone therapy for systemic lupus erythematosis. Am J Gastroenterol. (53 year old woman with systemic lupus had rise of ALT [144 rising to 658 U/L] arising 38 days after starting oral prednisolone therapy [20 mg/day], liver biopsy showing steatohepatitis; patient reported to have died of liver failure subsequently, but no clinical details given).
Shiota G, Harada K, Oyama K, Udagawa A, Nomi T, Tanaka K, Tsutsumi A, et al. (2000). Severe exacerbation of hepatitis after short-term corticosteroid therapy in a patients with "latent" chronic hepatitis B. Liver. (46 year old woman with polyneuropathy developed hepatitis after each of 3 pulses of methylprednisolone [1 g/day for 3 days], twice with jaundice [bilirubin normal, rising to 20 mg/dL, ALT 500-1500 U/L, no detectable HBsAg, but “occult” HBV DNA identified in liver).
Weissel M, Hauff W. (2000). Fatal liver failure after high-dose glucocorticoid pulse therapy in a patient with severe thyroid eye disease. Thyroid. (71 year old woman with Graves disease developed hepatitis after fifth monthly cycle of high dose methylprednisolone [1 g/day for 3 days], with acute liver failure, death and massive necrosis on autopsy; patient also on methimazole and few clinical details given).
Marcocci C, Bartalena L, Tanda ML, Manetti L, Dell'Unto E, Rocchi R, Barbesino G, et al. (2001). Comparison of the effectiveness and tolerability of intravenous or oral glucocorticoids associated with orbital radiotherapy in the management of severe Graves' ophthalmopathy: results of a prospective, single-blind, randomized study. J Clin Endocrinol Metab. (Controlled trial of intravenous methylprednisolone [15 mg/kg in 4 cycles] vs oral prednisone [starting at 100 mg/day] in 82 patients with Graves’ ophthalmopathy; one methylprednisolone treated patient had marked, asymptomatic increase in ALT at end of treatment, with recovery in 2 months; authors also mention an unpublished fatal case that they had seen before).
Dourakis SP, Sevastianos VA, Kaliopi P. (2002). Acute severe steatohepatitis related to prednisolone therapy. Am J Gastroenterol. (67 year old woman with dermatomyositis developed jaundice after 8 days of intravenous prednisolone [75 mg/day] [bilirubin 10.8 mg/dL, ALT 545 U/L, Alk P 467 U/L, negative ANA], resolving on decreasing dose, but patient died of pneumonia shortly thereafter, liver histology showing severe fat without fibrosis).
Stravitz RT, Sanyal AJ. (2003). Drug-induced steatohepatitis. Clin Liver Dis. (Review of drugs that can cause steatohepatitis including glucocorticoids; mechanism unknown).
Candelli M, Nista EC, Pignataro G, Zannoni G, de Pascalis B, Gasbarrini G, Gasbarrini A. (2003). Steatohepatitis during methylprednisolone therapy for ulcerative colitis exacerbation. J Intern Med. (25 year old man with ulcerative colitis developed elevated ALT [106 U/L], fatty liver by ultrasound, and steatohepatitis on liver biopsy 40 days after starting oral methylprednisolone, ALT elevations and ultrasound changes resolving within 6 months of stopping).
Marinó M, Morabito E, Brunetto MR, Bartalena L, Pinchera A, Marocci C. (2004). Acute and severe liver damage associated with intravenous glucocorticoid pulse therapy in patients with Graves' ophthalmopathy. Thyroid. (Among 800 patients with Graves ophthalmopathy treated with intravenous methylprednisolone, 7 [~1%] developed acute hepatitis-like illness following 3-6 courses, ages 30-63 years, arising 3-17 weeks after starting, 3 were jaundiced and died, 4 were asymptomatic [ALT 179-2490 U/L, Alk P 100-498 U/L], autoantibodies uncommon, resolving spontaneously in 9-22 weeks).
Salvi M, Vannucchi G, Sbrozzi F, Del Castello AB, Carnevali A, Fargion S, Beck-Peccoz P. (2004). Onset of autoimmune hepatitis during intravenous steroid therapy for thyroid-associated ophthalmopathy in a patient with Hashimoto's thyroiditis: case report. Thyroid. (43 year old woman with ophthalmopathy developed hepatitis after fourth course of methylprednisolone [ALT rising to 1152 U/L, ANA positive], responding to oral prednisone in tapering doses, but still on low doses of prednisone [2.5 mg/day] 6 years later).
Marinò M, Morabito E, Altea MA, Ambrogini E, Oliveri F, Brunetto MR, Pollina LE, et al. (2005). Autoimmune hepatitis during intravenous glucocorticoid pulse therapy for Graves' ophthalmopathy treated successfully with glucocorticoids themselves. J Endocrinol Invest. (43 year old woman with ophthalmopathy who developed marked ALT elevations [1419 U/L] with normal bilirubin and Alk P levels after 3 pulse cycles of methylprednisolone, ANA negative, but biopsy showed chronic aggressive hepatitis which responded to oral prednisone therapy).
Hofstee HM, Nanayakkara PW, Stehouwer CD. (2005). Acute hepatitis related to prednisolone. Eur J Intern Med. (46 year old woman with multiple sclerosis developed marked ALT elevations [peak levels 1095, ~1550 and ~2300 U/L with Alk P 140 U/L, LDH 473 U/L, ANA negative] 4-6 weeks after methylprednisolone pulse therapy on multiple occasions, always without jaundice and resolving rapidly each time).
Das D, Graham I, Rose J. (2006). Recurrent acute hepatitis in patient receiving pulsed methylprednisolone for multiple sclerosis. Indian J Gastroenterol. (48 year old woman developed nausea and jaundice 6 weeks after a third course of high dose pulse methylprednisolone for multiple sclerosis [bilirubin ~12 rising to ~35 mg/dL, ALT 1625 U/L, Alk P 210 U/L, ANA negative], resolving in 1-2 months and recurring 1 year later after a fourth course).
Topal F, Ozaslan E, Akbulut S, Küçükazman M, Yüksel O, Altiparmak E. (2006). Methylprednisolone-induced toxic hepatitis. Ann Pharmacother. (47 year old woman developed jaundice one week after finishing 7 day course of methylprednisolone [32 mg/day] [bilirubin rising to 15 mg/dL, ALT 2478 U/L, Alk P 138 U/L, ANA negative], resolution in 8 weeks, also on topiramate which was also stopped, but restarted briefly).
Reuß R, Retzlaff K, Vogel S, Franke FE, Oschmann P. (2007). Autoimmune hepatitis after high-dose intravenous methylprednisolone pulse in RR-MS. CEJ Med. (42 year old woman with multiple sclerosis developed elevations in ALT [1082 U/L] without jaundice 3 weeks after second pulse of intravenous methylprednisolone; liver biopsy showed necrosis, collapse and fibrosis, levels slowly improved; no mention of ANA or bilirubin levels).
Le Moli R, Baldeschi L, Saeed P, Regensburg N, Mourits MP, Wiersinga WM. (2007). Determinants of liver damage associated with intravenous methylprednisolone pulse therapy in Graves' ophthalmopathy. Thyroid. (Among 27 patients with Graves ophthalmopathy receiving 1-4 pulses of methylprednisolone, 7 had transient ALT elevations [peak level 120 U/L] shortly after infusion, all resolved and none were jaundiced).
Takahashi A, Kanno Y, Takahashi Y, Sakamoto N, Monoe K, Saito H, Abe K, et al. (2008). Development of autoimmune hepatitis type 1 after pulsed methylprednisolone therapy for multiple sclerosis: a case report. World J Gastroenterol. (43 year old woman with multiple sclerosis developed acute hepatitis 1 month after third course of pulse methylprednisolone [1 g/day for 3 days] [bilirubin 3.4 mg/dL, ALT 1067 U/L, Alk P 377 U/L, IgG 1370 mg/dL, ANA negative] with bilirubin rising to 19.1 mg/dL, attributed to beta interferon; but developed hepatitis again 2 weeks after a subsequent pulse of methylprednisolone [bilirubin 1.7 mg/dL, ALT 875 U/L, Alk P 214 U/L, IgG 1785 mg/dL and ANA 1:80], resolving with oral prednisolone therapy).
Rivero Fernández M, Riesco JM, Moreira VF, Moreno A, López San Román A, Arranz G, Ruiz Del Arbol L. (2008). Rev Esp Enferm Dig. (57 year old woman with multiple sclerosis developed ALT elevations after each of 3 pulse cycles of methylprednisolone [peak ALT 1223, 833 and 2685 U/L, Alk P 113 and 115 U/L, ANA negative] without jaundice and with rapid resolution, biopsy showing acute hepatitis with “lytic” necrosis).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to corticosteroid therapy or methylprednisolone).
Hoofnagle JH. (2009). Reactivation of hepatitis B. Hepatology. (Review of reactivation of hepatitis B as caused by chemotherapy or immunosuppression).
Loraschi A, Banfi P, Mauri M, Sessa F, Bono G, Cosentino M. (2010). Hepatotoxicity after high-dose methylprednisolone for demyelinating disease. Clin Neuropharmacol. (One man and one woman, ages 33 and 27 years with demyelinating disease developed abnormal ALT levels [1042 U/L and 122 U/L] 5 and 1 week after starting high dose methylprednisolone therapy [4 and 6 days of 2.5 and 4.5 g], resolving rapidly; no mention of symptoms or jaundice).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to methylprednisolone or other corticosteroids).
Gutkowski K, Chwist A, Hartleb M. (2011). Liver injury induced by high-dose methylprednisolone therapy: a case report and brief review of the literature. Hepat Mon. (24 year old woman with multiple sclerosis developed jaundice 4 weeks after a pulse of methylprednisolone and 1 week after 2 doses of interferon beta [bilirubin 17.9 mg/dL, ALT 740 U/L, Alk P 186 U/L, prothrombin index 35%, SMA >1:320], resolving spontaneously, but recurring after another pulse of methylprednisolone with interferon beta [bilirubin 7.3 mg/dL, ALT 1129 U/L, Alk P 164 U/L], again resolving spontaneously).
Furutama D, Kimura F, Shinoda K, Maeda T, Tanaka T, Ohsawa N. (2011). Recurrent high-dose intravenous methylprednisolone succinate pulse therapy-induced hepatopathy in a patient with multiple sclerosis. Med Princ Pract. (11 year old girl with multiple sclerosis had 3 episodes of marked serum ALT elevations [peak levels ~700-1400 U/L] 1-2 months after bolus therapy with methylprednisolone, with minimal symptoms and no jaundice or bilirubin elevations).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, of which none were attributed to corticosteroids or methylprednisolone).
Carrier P, Godet B, Crepin S, Magy L, Debette-Gratien M, Pillegand B, Jacques J, et al. (2013). Acute liver toxicity due to methylprednisolone: consider this diagnosis in the context of autoimmunity. Clin Res Hepatol Gastroenterol. (30 year old woman with multiple sclerosis developed jaundice 3 weeks after a second bolus dose of methylprednisolone [bilirubin 25.8 mg/dL, ALT 547 U/L, Alk P 141 U/L, ANA negative], with rapid resolution on stopping and recurrence 2 and 5 years later with subsequent single bolus doses of methylprednisone [peak bilirubin 6.6 and 9.6 mg/dL, ALT 415 and 2826 U/L and Alk P 60 and 148 U/L, latency 10-20 days]).
D'Agnolo HM, Drenth JP. (2013). High-dose methylprednisolone-induced hepatitis in a patient with multiple sclerosis: a case report and brief review of literature. Neth J Med. (48 year old woman developed abdominal pain and nausea 19 days after high dose methylprednisolone for multiple sclerosis [bilirubin 1.7 mg/dL, ALT 3028 U/L, GGT 182 U/L], resolving within the following few weeks; by history, she had a similar event 14 years earlier, but did not develop clinically apparent liver injury after 3 subsequent courses of oral dexamethasone [200 mg/day]).
Melamud B, Lurie Y, Goldin E, Levi I, Esayag Y. (2014). Methylprednisolone-induced liver injury: a diagnostic challenge. Isr Med Assoc J. (52 year old man with Graves disease developed liver injury within a few weeks of intravenous methylprednisolone, which recurred when he received a second course [bilirubin 3.4 mg/dL, ALT 465 U/L, Alk P 80 U/L], resolving on no therapy within 7 months).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to budesonide or methylprednisolone or other corticosteroids).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 2 were attributed to high dose methylprednisolone, but none to budesonide or other corticosteroids).
Juan J, Feld JJ. (2014). Hepatitis B virus and hepatitis C virus treatment and management in patients receiving immune-modifying agents. Curr Opin Rheumatol. (Review of reactivation of hepatitis B and C by chemotherapeutic and immune-modifying agents including corticosteroid based therapies).
Ferraro D, Mirante VG, Losi L, Villa E, Simone AM, Vitetta F, Federzoni L, et al. (2015). Methylprednisolone-induced toxic hepatitis after intravenous pulsed therapy for multiple sclerosis relapses. Neurologist. (Short summaries of 4 cases of liver injury after high dose intravenous methylprednisolone therapy of multiple sclerosis, all 4 were women, ages 24 to 50 years, usually with onset within 1 month, peak ALT levels of 260-494 U/L, evidently without jaundice, and resolving spontaneously, but recurring with reexposure).
(2015). High-dose intravenous methylprednisolone: liver injury. Prescrire Int. (Summary of a recent Canadian drug regulatory agency review of 32 cases [4 new] of acute liver injury after intravenous methylprednisolone therapy which were accompanied by jaundice in 10, recurred with rechallenge in 11 and resulted in death in 4).
Davidov Y, Har-Noy O, Pappo O, Achiron A, Dolev M, Ben-Ari Z. (2016). Methylprednisolone-induced liver injury: Case report and literature review. J Dig Dis. (23 year old Israel woman with multiple sclerosis developed jaundice three weeks after receiving a 3 day course of high dose methylprednisolone [bilirubin 6.9 mg/dL, ALT 2011 U/L, Alk P 148 U/L, INR 1.18], biopsy showing zone 3 necrosis and inflammation, resolving rapidly; had a previous history of similar episode 3 years earlier).
Moleti M, Giuffrida G, Sturniolo G, Squadrito G, Campennì A, Morelli S, Puxeddu E, et al. (2016). Acute liver damage following intravenous glucocorticoid treatment for Graves' ophthalmopathy. Endocrine. (2 patients with Graves’ ophthalmopathy developed liver enzyme elevations during high dose methylprednisolone therapy, 58 year old man and 50 year old women, arising after 5th and 3rd weekly infusions [ALT 809 and 822 U/L, GGT 112 and normal, bilirubin normal or not given], with spontaneous resolution 12 and 16 weeks after stopping).
Sayin R, Gokgul A, Ebinc S, Dulger AC, Tombul T. (2016). Clinical overlap of multiple sclerosis and autoimmune hepatitis: three cases. J Coll Physicians Surg Pak. (Description of 3 patients with multiple sclerosis and features of autoimmune hepatitis, two of whom were receiving interferon beta and the third with preexisting autoimmune hepatitis found to have brain imaging changes suggestive of multiple sclerosis).
Dumortier J, Cottin J, Lavie C, Guillaud O, Hervieu V, Chambon-Augoyard C, Scoazec JY, et al. (2017). Methylprednisolone liver toxicity: A new case and a French regional pharmacovigilance survey. Clin Res Hepatol Gastroenterol. (27 year old woman with multiple sclerosis treated with multiple agents had repeated bouts of acute liver injury arising within a month of pulse methylprednisolone therapy that was sometimes clinically apparent [bilirubin 3.7 mg/dL, ALT 1704 U/L, GGT 124 U/L] and resolved within a few months of stopping, later tolerating fingolimod; review of a French pharmacovigilance registry identified 4 other cases of severe injury attributed to high dose, pulses of methylprednisolone).
Abramavicius S, Velickiene D, Kadusevicius E. (2017). Methimazole-induced liver injury overshadowed by methylprednisolone pulse therapy: Case report. Medicine (Baltimore). (74 year old woman with Graves’ ophthalmopathy was treated with methimazole and pulses of methylprednisolone and developed mild-to-moderate ALT elevations after the 4th pulse that continued until the 9th pulse and eventually resolved despite continuing both drugs).
Bresteau C, Prevot S, Perlemuter G, Voican C. (2018). Methylprednisolone-induced acute liver injury in a patient treated for multiple sclerosis relapse. BMJ Case Rep. (35 year old woman with 13 year history of multiple sclerosis developed acute liver injury 2 months after a 5 day course of high dose methylprednisolone [bilirubin 2.9 mg/dL, ALT 1512 U/L, Alk P 86 U/L, GGT 109 U/L], resolving within 6 weeks).
Nociti V, Biolato M, De Fino C, Bianco A, Losavio FA, Lucchini M, Marrone G, et al. (2018). Liver injury after pulsed methylprednisolone therapy in multiple sclerosis patients. Brain Behav. (Among 175 patients with multiple sclerosis receiving 251 cycles of high dose intravenous methylprednisolone, 21 [8.6%] developed de novo ALT elevations after therapy, which were transient and mild in 15 but severe in 6 [3.4%: bilirubin 1.3 to 10.8 mg/dL, ALT 778 to 2956 U/L, Alk P 91 to 350 U/L, hepatocellular in all], resolving in 4 subjects but evolving into chronic hepatitis suspected to be autoimmune in 2 both of whom required long term immunosuppressive therapy).
Adamec I, Pavlović I, Pavičić T, Ruška B, Habek M. (2018). Toxic liver injury after high-dose methylprednisolone in people with multiple sclerosis. Mult Scler Relat Disord. (Three women, ages 37 to 46 years, with multiple sclerosis developed acute liver injury after infusions of high dose, intravenous methylprednisolone [ALT 2259, 395 and 1340 U/L], recurring with milder ALT elevations upon reexposure [ALT 140, 134, and 85 U/L], and with no evidence of injury with lower doses).
Rotondo E, Graziosi A, Di Stefano V, Mohn AA. (2018). Methylprednisolone-induced hepatotoxicity in a 16-year-old girl with multiple sclerosis. BMJ Case Rep. (16 year old girl with recent onset of multiple sclerosis developed an acute hepatitis a month after a 5 day course of intravenous methylprednisolone [bilirubin 2.1 mg/dL, ALT 2438 U/L, GGT 68 U/L], resolving spontaneously within 2 months of onset).
Zoubek ME, Pinazo-Bandera J, Ortega-Alonso A, Hernández N, Crespo J, Contreras F, Medina-Cáliz I, et al. (2019). Liver injury after methylprednisolone pulses: A disputable cause of hepatotoxicity. A case series and literature review. United European Gastroenterol J. (Three women, ages 31 to 36 years, with multiple sclerosis developed acute liver injury 2-6 weeks after receiving a 3-7 day course of intravenous methylprednisolone [bilirubin 3.6, 0.8 and 13.9 mg/dL, ALT 2194, 630 and 2737 U/L, Alk P 229, 193 and 169 U/L], resolving spontaneously and recurring with reexposure in two patients).
Nguyen N, Reddy YK, Jain N, Patel V, James D, Sistani B, Steinberg H. (2019). Challenges in management of autoimmune hepatitis with concurrent Graves thyrotoxicosis. ACG Case Rep J. (37 year old African American woman with Graves’ disease developed jaundice [bilirubin 9.4 mg/dL, direct 13 mg/dL, ALT 2725 U/L, Alk P 314 U/L, IgG 1910, ANA negative] and was treated with iv methylprednisolone followed by oral prednisone, with remission in disease on long term immunosuppression).
Cottin J, Pierre S, Pizzoglio V, Simon C, Durrieu G, Bleyzac N, Gouraud A, et al. (2020). Methylprednisolone-related liver injury: A descriptive study using the French pharmacovigilance database. Clin Res Hepatol Gastroenterol. (Analysis of all cases of liver injury after exposure to methylprednisolone [MP] from the French pharmacovigilance database [2016] identified 414 persons exposed, 97 being judged due to MP; 59% women, mean age 46 years; used for autoimmune disease in 48%, multiple sclerosis in 27%, given iv in 79%, mean time to onset 9.5 days but as long as 9 months after starting; hepatocellular injury in 73%, mild course in 45%, moderate 45%, fatal in 3, but usually with rapid recovery, rechallenge in 13 cases led to recurrence in 10 [77%]).
Milovanovic T, Jankovic K, Boricic I, Dragasevic S, Stojkovic Lalosevic M, Dumic I. (2020). Methylprednisolone induced liver injury in a patient with multiple sclerosis. J Gastrointestin Liver Dis. (28 year old woman with multiple sclerosis developed evidence of liver injury after a second monthly course of methylprednisolone [3 gm over 3 days] without jaundice [ALT 459 U/L, bilirubin and Alk P normal, ANA negative], resolving after discontinuation).
Kimura H, Takeda A, Kikukawa T, Hasegawa I, Mino T, Uchida-Kobayashi S, Ohsawa M, et al. (2020). Liver injury after methylprednisolone pulse therapy in multiple sclerosis is usually due to idiosyncratic drug-induced toxicity rather than autoimmune hepatitis. Mult Scler Relat Disord. (Between 2005 and 2016, 8 patients with multiple sclerosis developed liver injury after pulse methylprednisolone therapy, all women, ages 28 to 49 years, developing hepatocellular injury 4-90 days after starting MP, peak ALT 170 to 2720 U/L, with mild jaundice only, spontaneous recovery in 1-7 months, and liver biopsies in 6 showing acute centrilobular necrosis in 5 with no fibrosis and possible autoimmune hepatitis in one).
RECOVERY Collaborative Group. (2021). Dexamethasone in hospitalized patients with Covid-19. N Engl J Med. (Among 6425 hospitalized patients with COVID 19 enrolled in a large multicenter pragmatic trial, the 28 day mortality was lower among those who received dexamethasone [6 mg daily for up to 10 days] versus those receiving usual care alone [22.9% vs 25.7%], the decrease in mortality being seen in those on mechanical ventilation [29.3% vs 41.4%] or receiving oxygen [23.3% vs 26.2%], but not in those receiving no respiratory support [17.8% vs 14%]; there were no serious hepatic adverse events or deaths from liver injury).
Tomazini BM, Maia IS, Cavalcanti AB, Berwanger O, Rosa RG, Veiga VC, Avezum A, et al., COALITION COVID-19 Brazil III Investigators. (2020). Effect of dexamethasone on days alive and ventilator-free in patients with moderate or severe acute respiratory distress syndrome and COVID-19: The CoDEX Randomized Clinical Trial. JAMA. (Among 299 hospitalized patients with COVID-19 pneumonia and moderate-to-severe respiratory distress syndrome admitted to 41 ICUs in Brazil, those treated with dexamethasone for up to 10 days had more ventilator free days during the first 28 days than those receiving standard care [6 vs 4.4 days], although overall mortality was similar [56.3% vs 61.5%] as were severe adverse events including infections and hyperglycemia; no hepatic severe adverse events reported).
WHO Rapid Evidence Appraisal for COVID-19 Therapies (REACT) Working Group. (2020). Association between administration of systemic corticosteroids and mortality among critically ill patients with COVID-19: a meta-analysis. JAMA. (Metaanalysis of efficacy and safety of systemic corticosteroids in critically ill patients with COVID-19 identified 7 randomized controlled trials with a total of 1703 patients and concluded that systemic corticosteroid therapy [dexamethasone, methylprednisolone, or hydrocortisone] was associated with a lower all-cause mortality at 28 days with a summary odds ratio of 0.70, while severe adverse event rates were similar in frequency).
Melquist S, Estepp K, Aleksandrovich Y, Lee A, Beiseker A, Hamedani FS, Bassett J. (2020). COVID-19 presenting as fulminant hepatic failure: A case report. Medicine (Baltimore). (35 year old woman with lupus erythematosus developed abdominal pain and jaundice and upon admission was found to be positive for SARS-CoV-2 RNA [bilirubin 7.0 2 days later rising to 10.5 mg/dL, ALT 278 rising to 5,524 stable at 171 U/L, Alk P 200 U/L and INR 1.5 rising to 4.8] with rapid onset of hepatic encephalopathy, but subsequent spontaneous recovery while developing only mild symptoms of COVID-19).
Jamaati H, Hashemian SM, Farzanegan B, Malekmohammad M, Tabarsi P, Marjani M, Moniri A, et al. (2021). No clinical benefit of high dose corticosteroid administration in patients with COVID-19: A preliminary report of a randomized clinical trial. Eur J Pharmacol. (Among 50 hospitalized patients with mild-to-moderate COVID 19 treated with dexamethasone or standard care, overall mortality was similar in the two groups [64% vs 60%] as was need for mechanical ventilation [52% vs 44%] and duration of hospital stay [11 vs 6 days]; no discussion of adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Corticosteroids: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Corticosteroids/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2 Trials on Corticosteroids: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Corticosteroids)